# Tagraxofusp

## OVERVIEW

### Introduction

Tagraxofusp is a recombinant fusion protein consisting of the binding site of interleukin 3 [IL3] fused with diphtheria toxin and that is given by intravenous infusion and used as an antineoplastic agent for patients with blastic plasmacytoid dendritic cell neoplasm. Treatment with tagraxofusp is associated with a high rate of serum enzyme elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury with jaundice.

### Background

Tagraxofusp (tag rax' oh fusp) is a recombinant fusion protein that combines the binding site domain of IL3 with the catalytic domain of diphtheria toxin. The IL3 domain targets cells with the IL3 receptor (CD122), which is highly expressed on some malignant myeloid cells and particularly cells of blastic plasmacytoid dendritic cell neoplasm (BPDCN), a rare, aggressive myeloid malignancy that is universally fatal without treatment, overall survival for which is 7 to 12 months. Clinical trials of tagraxofusp in small numbers of patients with BPDCN showed response rates of approximately 50%, higher than is achieved with conventional cancer chemotherapy. Tagraxofusp received accelerated approval for BPDCN in both adults and children (2 years or older) in the United States in 2018 and is available in solution in single dose vials of 1,000 mcg/mL under the brand name Elzonris. The recommended dose is 12 mcg/kg intravenously on days 1 to 5 of 21-day cycles. Side effects are common and therapy should be administered only in inpatient facilities or in specialty outpatient settings. Common side effects include capillary leak syndrome (>50%), fatigue, nausea, fever, peripheral edema, anemia, thrombocytopenia, hypocalcemia, hyponatremia and hypoglycemia. Severe adverse reactions include severe capillary leak syndrome, hypersensitivity reactions and severe, even life-threatening capillary leak syndrome. Tagraxofusp should be administered only by health care groups with experience in cancer chemotherapy and management of its severe complications.

### Hepatotoxicity

In prelicensure clinical trials of tagraxofusp, serum enzyme elevations arose in 88% of patients and ALT or AST values were above 5 times ULN in 40%. Serum alkaline phosphatase elevations were also common [26%] as were bilirubin elevations [14%], but were usually mild and self-limited, resolving rapidly despite continuation of therapy. The liver test abnormalities typically arose between days 7 and 14 of chemotherapy cycles and highest levels occurred with the first several doses. At least temporary discontinuation of tagraxofusp was reported in 19% of treated patients. The overall clinical experience with tagraxofusp has been limited, but it has not been linked to instances of clinically apparent acute liver injury with symptoms or jaundice. Because of this limited clinical experience, tagraxofusp’s potential for causing liver injury is not well defined.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

The possible cause of the liver injury due to tagraxofusp is not known. Tagraxofusp is a recombinant protein and is metabolized by many cells, but mostly those that have receptors for CD122 and take up the protein. The delivered diphtheria toxin is a direct cytoplastic toxin and would injure any cells that possess CD122 receptors. Thus, low levels of the CD122 receptor on hepatocytes or endothelial cells might account for its hepatotoxicity. In addition, antibodies to diphtheria toxin (as a result of DPT vaccination) are common in the general population and the administration of tagraxofusp might lead to immune complex formation which might be taken up by hepatocytes or macrophages.

### Outcome and Management

Routine monitoring of liver tests is recommended in patients receiving tagraxofusp therapy at the time of each infusion. Patients with ALT or AST elevations of more than 5 times ULN should discontinue tagraxofusp at least temporarily and restarted only once the abnormalities have resolved.

Drug Class: Antineoplastic Agents, Cytokines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tagraxofusp – Elzonris®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tagraxofusp)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Tagraxofusp | 2055491-00-2 | Fusion Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 April 2019

Abbreviation: BPDCN, blastic plasmacytoid dendritic cell neoplasm.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of fusion proteins and tagraxofusp).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of tagraxofusp and other therapeutic fusion proteins).
Wellstein A, Giaccone G, Atkins MB, Sausville EAl. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that capillary leak syndrome was the only fatal toxicity seen and that serum enzyme elevations were frequent but generally transient and not associated with symptoms or jaundice).
Syed YY. Tagraxofusp: first global approval. Drugs 2019; 79: 579-83. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of tagraxofusp shortly after its approval in the US; mentions that it has “manageable safety and tolerability” and that liver enzyme elevations occur in 88% of patients which are above 5 times ULN in 36% and above 20 times ULN in 4%; the abnormalities being the most frequent reason for early discontinuation). 30859413
Alkharabsheh O, Frankel AE. Clinical activity and tolerability of SL-401 (Tagraxofusp): Recombinant diphtheria toxin and interleukin-3 in hematologic malignancies. Biomedicines 2019; 7. pii: E6. (Review of the structure, mechanism of action, preclinical and clinical studies and safety of tagraxofusp; mentions that “transaminitis has been reported across trials, but it was reversible” and elevations were generally less than 20 times ULN). 30621282

## OTHER REFERENCE LINKS

1. Recent References on Tagraxofusp: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tagraxofusp/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Tagraxofusp: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tagraxofusp)